# Migraine Headache Agents

## OVERVIEW

Migraine headaches are marked by repeated, paroxysmal attacks of moderate-to-severe throbbing, one-sided headaches which (without treatment) last 4 to 72 hours and are usually associated with symptoms of nausea and vomiting. Migraine headaches are typically exacerbated by motion, bright lights and loud noises. Migraines may be associated with focal neurological symptoms referred to as “aura” which are typically visual, but may be sensory or motor. Migraine headaches are common, affecting at least 18% of women and 6.5% of men in the United States. The pattern of paroxysmal headaches typically arises in adolescence or young adulthood and may be life-long. The headaches often interfere with daily activities and can be incapacitating, result in major time lost from work and precipitate multiple physician and emergency room visits. Patients with migraine may also be at increased risk for other vascular complications such as stroke and eclampsia.

The cause of migraine headaches is not fully understood, but appears to be related to arteriolar vasodilation and inflammation of the trigeminal nerve endings, perhaps caused by local release of vasoactive peptides. Serotonin activity appears to lessen the pain and symptoms of migraine and serotonin receptor agonists have been developed that have activity against acute migraine. However, the most convincing candidate mediator of migraines is the calcitonin gene related protein (CGRP), a neuropeptide with potent vasodilator and pain-signaling activities. CGRP is found throughout the central and peripheral nervous systems but is particularly active in trigeminal ganglia. Circulating levels of CGRP are elevated in patients with migraines, and the efficacy of migraine therapies such as serotonin receptor agonists and ergot alkaloids is associated with lowering of circulating CGRP levels. Antagonists of CGRP have become a focus of migraine headache prevention and therapy.

Therapy of migraine headache usually combines preventive treatments with early intervention for acute attacks. Early treatment approaches to migraine have included a number of different classes of medications, including analgesics such as aspirin, nonsteroidal antiinflammatory agents and opiates, barbiturates, antiemetics, ergot alkaloids, two types of serotonin receptor agonists (triptans and ditans), and oral, small molecule CGRP antagonists.

For mild migraine headaches, commonly used analgesics such as NSAIDS and aspirin are often effective. They are approved for therapy of headaches, but not specifically for migraine headaches. Opiate analgesics should be avoided. Other medications such as barbiturates and antiemetics are often used, but treat some of the other symptoms of migraine such as nausea and dizziness.

The ergot alkaloids are generally the first line of therapy for migraines. They are inexpensive and have been in use for many years. They do have side effects that can be severe. Currently available forms include ergotamine (Cafergot: year of approval, 1948) and dihydroergotamine (Migranal: 1946). They are used only for treatment of acute attacks.

The triptans which are specific agonists of the serotonin 5-HT_1B/D_ receptors, are perhaps the most reliable and most common used therapies for acute migraine. Triptans in current use include sumatriptan (Imitrex: 1997), zolmitriptan (Zomig: 1997), naratriptan (Amerge: 1998), rizatriptan (Maxalt: 1998), almotriptan (Almogran, Axert: 2001), frovatriptan (Frova: 2001), and eletriptan (Relpax: 2002). Most of these are now available in generic and less expensive forms.

The ditans are highly selective 5-HT_1F_ receptor agonists and lack the vasoconstrictive activity of the triptans. The sole ditan approved for use in migraine headache is lasmiditan (Reyvow: 2019). Lasmiditan has had limited clinical use and, because of its price and relatively modest degree of efficacy, is usually limited to patients in whom triptans are contraindicated or have failed to control severe migraine attacks.

The identification of CGRP as an important mediator of vasodilation and pain in patients with migraine led to development of potent and well tolerated small molecule, oral CGRP antagonists as agents to treat acute attacks as well as long acting, monoclonal antibodies to CGRP or its receptor to prevent episodic and chronic migraine. The small molecule CGRP receptor inhibitors include ubrogepant (Ubrelvy: 2019) and rimegepant (Nurtec-ODT: 2020). These agents (the “gepants”) are given by mouth at the time of onset of migraine and have not been approved for chronic use to prevent migraines. The monoclonal antibodies to CGRP include fremanezumab (Ajovy: 2018), galcanezumab (Emgality: 2018) and eptinezumab (Vyepti: 2019) and the CGRP receptor, erenumab (Aimovig: 2018). These agents are given subcutaneously once monthly or every three months and have been found to reduce the frequency of migraines but rarely to eliminate them completely. They are not effective in treatment of ongoing, acute migraine.

Other therapies for prevention of migraine are mostly used off label and have limited efficacy. These preventive agents include valproate, topiramate, various beta-blockers, candesartan, antidepressants, and botulinum toxin type A.

The ergot alkaloids, triptans and ditans rarely if ever cause liver injury, perhaps because they are used for a short time only and in low doses. The monoclonal antibody and small molecule antagonists to CGRP have had limited general use, but appear to be free of significant hepatotoxicity. Rare instances of clinically apparent liver injury have been described in patients taking zolmitriptan and rizatriptan.

General references on the safety and hepatotoxicity of the drugs used specifically for migraine are provided with this introductory section. References specific to the individual agents are provided in separate chapters on the general class of agents (ergot alkaloids and the triptans) or on the specific individual agent.

The following links are to individual drug records.

- Ergot Alkaloids: Ergotamine, Dihydroergotamine
- Monoclonal Antibodies: Eptinezumab, Erenumab, Fremanezumab, Galcanezumab
- Small Molecule CGRP Receptor Antagonists: Atogepant, Rimegepant, Ubrogepant, Zavegepant
- Serotonin-1B/D (5-HT_1B/D_) Receptor Agonists, Triptans: Almotriptan, Eletriptan, Frovatriptan, Naratriptan, Rizatriptan, Sumatriptan, Zolmitriptan
- Serotonin-1F (5-HT_1F_) Receptor Agonists, Ditans: Lasmiditan

## ANNOTATED BIBLIOGRAPHY

References updated: 22 July 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; drugs for migraine headache are not discussed).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of hepatotoxicity of neuroleptic drugs, does not mention the drugs for migraine headache).
Sibley DR, Hazelwood LA, Amara SG. Drugs affecting 5HT signaling. 5-Hydroxytryptamine (serotonin) and dopamine. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 231-4. (Textbook of pharmacology and therapeutics).
Geraud G, Compagnon A, Rossi A; COZAM Study Group. Zolmitriptan versus a combination of acetylsalicylic acid and metoclopramide in the acute oral treatment of migraine: a double-blind, randomised, three-attack study. Eur Neurol 2002; 47: 88-98. (Among 666 patients with migraine treated with either zolmitriptan or aspirin/metoclopramide, side effects of paresthesias and dizziness were more common with zolmitriptan; no mention of any hepatic side effects). 11844897
Diener HC, Jansen JP, Reches A, Pascual J, Pitei D, Steiner TJ; Eletriptan and Cafergot Comparative Study Group. Efficacy, tolerability and safety of oral eletriptan and ergotamine plus caffeine (Cafergot) in the acute treatment of migraine: a multicentre, randomised, double-blind, placebo-controlled comparison. Eur Neurol 2002; 47: 99-107. (Among 733 patients with migraine treated with either eletriptan or ergotamine/caffeine, side effects were transient and predominately mild or moderate; “No clinically significant laboratory…abnormalities were recorded”). 11844898
Snow V, Weiss K, Wall EM, Mottur-Pilson C; American Academy of Family Physicians; American College of Physicians-American Society of Internal Medicine. Pharmacologic management of acute attacks of migraine and prevention of migraine headache. Ann Intern Med 2002; 137: 840-9. (Guidelines for management of acute migraine and chronic prevention; recommends use of nasal dihydroergotamine or a triptan in patients whose migraines fail to respond to aspirin, acetaminophen or nonsteroidal antiinflammatory agents). 12435222
Jamieson DG. The safety of triptans in the treatment of patients with migraine. Am J Med 2002; 112: 135-40. (Review of the safety of triptans in migraine therapy focusing on vascular risk, stroke, myocardial infarction and ischemic bowel disease; no mention of hepatotoxicity). 11835952
Loj J, Solomon GD. Migraine prophylaxis: who, why, and how. Cleve Clin J Med 2006; 73: 793-4. (Preventive therapy of migraine has limited efficacy and may take 2-3 months to have an effect; the most commonly used agents are beta-blockers, calcium channel blockers, anticonvulsants, tricyclic antidepressants and selective serotonin reuptake inhibitors [SSRIs]). 16970133
Whyte CA, Tepper SJ. Adverse effects of medications commonly used in the treatment of migraine. Expert Rev Neurother 2009; 9: 1379-91. (Extensive review of common side effects of medications used to treat migraine; nausea is the most common and dose limiting side effect of ergot alkaloids and can require antiemetics; 1-8% of patients who take triptans develop “triptan sensations with throat and chest tightness, numbness and tingling and hot/cold sensations which may vary with different forms”). 19769452
Loder E. Triptan therapy in migraine. N Engl J Med 2010; 363: 63-70. (Review of the pathophysiology of migraine headache and the mechanism of action, efficacy, tolerance and safety of the serotonin receptor agonists [triptans]; no mention of ALT elevations of clinically apparent liver injury). 20592298
Taylor FR. Acute treatment of migraine headaches. Semin Neurol 2010; 30: 145-53. (Review of diagnosis and acute management of migraine headaches). 20352584
Drugs for migraine. Treat Guidel Med Lett 2011; 9: 7-12. (Concise review of current medications used for migraine; no discussion of hepatotoxicity). 21304447
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to drugs for migraine headaches). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to the triptans or other drugs for migraine headaches). 25754159
Edvinsson L. The CGRP pathway in migraine as a viable target for therapies. Headache 2018; 58 Suppl 1: 33-47. (Review of the calcitonin gene-related peptide [CGRP] and its receptor including their relationship to migraine headaches and development of small molecular inhibitors and monoclonal antibody therapies based upon their inhibition). 29697153
Tepper SJ. History and review of anti-calcitonin gene-related peptide (CGRP) therapies: from translational research to treatment. Headache 2018; 58 Suppl 3: 238-75. (Review of the role of CGRP in pathogenesis of migraine headaches and the development of small molecules and monoclonal antibody antagonists of CGRP actions). 30242830
Eptinezumab (Vyepti) for migraine prevention. Med Lett Drugs Ther 2020; 62: 85-7. (Concise review of the mechanism of action, clinical efficacy, safety and costs of eptinezumab in relation to other drugs for migraine prevention shortly after its approval in the US, states that it is modestly effective and that adverse events include nasopharyngitis and hypersensitivity reactions [1-2%] including angioedema; no mention of ALT elevations or hepatotoxicity). 32555116
Lasmiditan (Reyvow) and ubrogepant (Ubrelvy) for acute treatment of migraine. Med Lett Drugs Ther 2020; 62: 35-9. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ubrogepant and lasmiditan as therapy of acute migraine shortly after their approval for this indication in the US, mentions side effects of ubrogepant being nausea and somnolence but does not mention ALT elevations or hepatotoxicity). 32555120
Rimegepant (Nurtec ODT) for acute treatment of migraine. Med Lett Drugs Ther 2020; 62(1597): 70-2. (Concise review of the mechanism of action, pharmacology, clinical efficacy, safety and cost of rimegepant shortly after its approval in the US as therapy of acute migraine in adults, mentions that it “was generally well tolerated in clinical trials; nausea was the most common adverse event [~2%]”). 32555113
Drugs for migraine. Med Lett Drugs Ther 2020; 62: 153-60. (Concise summary of the relative clinical efficacy, safety and costs of drugs to treat acute migraine headache [such as analgesics, opiates, triptans, ergots and oral CGRP receptor antagonists] and to prevent migraines [such as anticonvulsants, beta blockers, antidepressants and monoclonal antibodies to CGRP and its receptor]). 33434187
Robbins MS. Diagnosis and management of headache: a review. JAMA 2021; 325: 1874-85. (Review of the diagnosis and management of headache including use of serotonin receptor agonists and calcitonin gene-related peptide antagonists for acute migraine attacks; no mention of ALT elevations or hepatotoxicity). 33974014